# Brompheniramine

## OVERVIEW

### Introduction

Brompheniramine and chlorpheniramine maleate are first generation antihistamines that are widely used to treat symptoms of allergic rhinitis and the common cold. Clinically apparent liver injury from brompheniramine or chlorpheniramine must be exceeding rare, if it occurs at all.

### Background

Brompheniramine (brome" fen ir' a meen) and chlorpheniramine (klor" fen ir' a meen) are first generation antihistamines that are used widely in the therapy of the symptoms of sneezing, cough, runny note, watery eyes and itching. They are similar in chemical structure and constitute the alkylamine class of antihistamines. They are probably the most commonly used over-the-counter antihistamines, being present alone or in combination with other agents in more than 1000 products used for the symptoms of the common cold, sinusitis, urticaria and hay fever. Both agents are also available as their dextrorotatory isomers, dexbrompheniramine and dexchlorpheniramine, which have similar profiles of action and side effects. Common brand name preparations include Chlor-Trimeton, Dimetane, Drixoral and Durahist, and most are available without a prescription and in combination with sympathomimetic agents (such as pseudoephedrine or phenylephrine) or analgesics or both. The typical oral dose in adults is 2 to 4 mg three or four times a day. Common side effects include sedation, impairment of motor function, confusion, dizziness, blurred vision, dry mouth and throat, palpitations, tachycardia, abdominal distress, constipation and headache. Antihistamines can worsen urinary retention and glaucoma.

Likelihood scores: E (unlikely to be a cause of clinically apparent liver injury).

### Hepatotoxicity

Despite widespread use, the first generation antihistamines such as brompheniramine and chlorpheniramine have rarely been linked to liver test abnormalities or to clinically apparent liver injury. A single case report of clinically apparent liver injury with jaundice attributed to dexchlorpheniramine was reported from France. The time to onset was 10 days, and the clinical presentation resembled acute viral hepatitis, with marked elevations in serum aminotransferase levels and jaundice. Recovery was rapid and complete, but jaundice and hepatitis recurred within 10 days of restarting. Immunoallergic features (rash, fever, eosinophilia) were absent as were autoantibodies. Interestingly, the patient tolerated other antihistamines (cetirizine) without difficulty.

### Mechanism of Injury

The reason for the relative safety of brompheniramine and chlorpheniramine may be due to low daily dose and limited duration of treatment. The rare instances of hepatic injury associated with dexchlorpheniramine may relate to hypersensitivity.

### Outcome and Management

Hepatic injury due to first generation antihistamines is very rare and most cases have been mild-to-moderate in severity and self-limited. Interestingly, recurrence of injury has been reported with reexposure to the same agent (dexchlorpheniramine, cetirizine, cyclizine, cyproheptadine), but not with switching to an unrelated antihistamine.

References on the safety and potential hepatotoxicity of antihistamines are given together after the Overview section on Antihistamines.

Drug Class: Antihistamines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Brompheniramine/Dexbrompheniramine – Generic, Ala-Hist®/Generic, Ala-Hist IR®

Chlorpheniramine/Dexchlorpheniramine – Generic, Chlor-Trimeton®/Generic

DRUG CLASS

Antihistamines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Brompheniramine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Brompheniramine | 86-22-6 | C16-H19-Br-N2 | Brompheniramine Chemical Structure
Chlorpheniramine | 132-22-9 | C16-H19-Cl-N2 | Chlorpheniramine Chemical Structure
Dexbrompheniramine | 132-21-8 | C16-H19-Br-N2 | Dexbrompheniramine Chemical Structure
Dexchlorpheniramine | 25523-97-1 | C16-H19-Cl-N2 | Dexchlorpheniramine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Brompheniramine and Chlorpheniramine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Brompheniramine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Brompheniramine and Chlorpheniramine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Brompheniramine)